# Azilsartan

## OVERVIEW

### Introduction

Azilsartan is an angiotensin II receptor blocker (ARB) used in the therapy of hypertension. It is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of acute liver injury.

### Background

Azilsartan (ay" sil sar' tan) is an ARB used alone or in combination with other agents for therapy of hypertension. Azilsartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II and which accounts for its antihypertensive activity. Azilsartan was approved for use in the United States in 2011 (the eighth ARB approved for hypertension). Current indications are for treatment of hypertension, either alone or in combination with other antihypertensive agents. Azilsartan is available in 40 and 80 mg tablets under the trade name Edarbi. Fixed combinations of azilsartan (40 mg) with chlorthalidone (12.5 or 25 mg) are also available under the brand name Edarbyclor. The typical dose in adults in 40 to 80 mg once daily, and it is used long term. Side effects are uncommon, but may include headache, dizziness, fatigue, cough, gastrointestinal upset, and fetal toxicity. Several ARBs, but not specifically azilsartan, have been linked to a severe sprue-like enteropathy that typically arises after months or years of therapy and is unresponsive to gluten withdrawal, but resolves promptly with stopping the angiotensin receptor antagonist.

### Hepatotoxicity

Azilsartan has been associated with a low rate of serum aminotransferase elevations that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. No specific instances of clinically apparent acute liver injury have been reported in association with azilsartan therapy, but it has been available for a limited time. Other ARBs have been linked to rare instances of symptomatic hepatotoxicity. The onset of liver injury is usually within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but ARB therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation.

Likelihood score: E* (Unproved but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations with azilsartan is not known. Azilsartan is metabolized at least in part by the liver, largely via CYP 2C9, but it has minimal drug-drug interactions.

### Outcome and Management

The instances of acute liver injury reported with ARB use have been self-limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with azilsartan induced liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of azilsartan are given in the Overview section on the Angiotensin II Receptor Antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Candesartan, Eprosartan, Irbesartan, Losartan, Olmesartan, Telmisartan, Valsartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Azilsartan – Edarbi®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Azilsartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Azilsartan | 147403-03-0 | C25-H20-N4-O5 | Azilsartan Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Azilsartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Azilsartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Azilsartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Azilsartan)